# Nabumetone

## OVERVIEW

### Introduction

Nabumetone is a long acting nonsteroidal antiinflammatory drug (NSAID) that is available by prescription only and is used in therapy of chronic arthritis. Nabumetone has been linked to rare instances of clinically apparent, idiosyncratic drug induced liver disease.

### Background

Nabumetone (nab ue' me tone) is a naphthyl alkanone and orally available antiinflammatory agent. Like other NSAIDs, nabumetone is a potent cyclo-oxygenase (Cox-1 and -2) inhibitor, which blocks the formation of proinflammatory prostaglandins that are important mediators in pain and inflammatory pathways. Nabumetone is a pro-drug and exerts anti-cyclo-oxygenase activity only after absorption and activation in the liver. Like other NSAIDs, it has analgesic, antipyretic, and antiinflammatory activities. Nabumetone was approved in the United States in 1991 but is now rarely used with fewer than 300,000 prescriptions filled yearly. Its current indications are limited to treatment of osteoarthritis and rheumatoid arthritis. Nabumetone is available by prescription only. Generic formulations are available of 500, 750 and 1000 mg; specific commercially available names include Relafen. The usual dose in adults is 1000 mg once daily, increasing to as much as 2000 mg daily based upon response and tolerance. As with other NSAIDs, nabumetone is generally well tolerated, but side effects can include headache, dizziness, somnolence, dyspepsia, nausea, abdominal discomfort, heartburn, peripheral edema and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as nabumetone include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, fetal toxicity, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Prospective studies show that 1% to 5% of patients taking nabumetone experience at least transient serum aminotransferase elevations. These may resolve even with drug continuation. Marked aminotransferase elevations (above 3 times ULN) occur in 0.5% of patients, a rate similar to that in placebo treated controls. Clinically apparent liver injury with jaundice from nabumetone is rare and in large clinical trials, no instances of acute liver injury with jaundice were reported. Since its approval and release, nabumetone has been reported to cause rare instances of serious hepatic adverse events (~1.3 per million prescriptions), but there have been no cases of clinically apparent liver injury due to nabumetone described in the published literature. Furthermore, nabumetone is not mentioned as a cause in large case series on drug induced liver injury or acute liver failure. Thus, the latency, clinical features and outcome of nabumetone induced liver injury have not been described and clinically apparent hepatotoxicity due to nabumetone must be very rare.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which nabumetone causes hepatotoxicity is not known. Nabumetone undergoes rapid biotransformation in the liver to methoxy-2-naphthylacetic acid, the principal active metabolite.

### Outcome and Management

The minor aminotransferase elevations that occur in a small proportion of patients during chronic therapy with nabumetone are usually subclinical and not progressive. The clinically apparent liver injury from nabumetone has not been characterized, but most NSAID related hepatotoxicity is self-limited and mild-to-moderate in severity. The cross reactivity in liver injury between various NSAIDs has not been well defined, but can occur. For these reasons, switching to another NSAID after clinically apparent liver injury from nabumetone should be done with caution.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nabumetone – Generic, Relafen®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?adv=1&labeltype=all&=&pagesize=20&page=1&query=Nabumetone%28Nabumetone%29+)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Nabumetone | 42924-53-8 | C15-H16-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2025

Abbreviations: NSAIDs, nonsteroidal antiinflammatory drugs.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; mentions an unpublished case of cholestatic hepatitis in a patient taking nabumetone).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Review of hepatotoxicity of NSAIDs mentions that nabumetone is associated with mild elevations in ALT in <1% of patients and that there have been no reports of severe liver injury).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Jackson RE, Mitchell FN, Brindley DA. Safety evaluation of nabumetone in United States clinical trials. Am J Med 1987; 83: 115-20. (Summary of safety evaluation of nabumetone in 1924 US patients with rheumatoid arthritis or osteoarthritis found similar pattern of adverse events to other NSAIDs; 18 patients [1%] had ALT >2 times ULN, but 6 had some degree of abnormality before therapy; no patient developed hepatitis or jaundice). 3318422
Jenner PN. A 12-month postmarketing surveillance study of nabumetone. A preliminary report. Drugs 1990; 40 (Suppl 5): 80-6. (Analysis of postmarketing surveillance of nabumetone using follow up forms sent to physicians; 7 gastrointestinal bleeds, one fatal; but no mention of cases of clinically apparent liver injury). 2081502
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroidal drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-38. (Extensive review article on liver injury due to NSAIDs; nabumetone is not discussed). 2281340
Bernhard GC. Worldwide safety experience with nabumetone. J Rheumatol Suppl 1992; 36: 48-57. (Summary of adverse effects in premarketing studies of nabumetone; 11 of 1677 patients had ALT elevations >3 times ULN, but all resolved with stopping; in postmarketing surveillance on 44,953 patients treated for 3 weeks to 8 years, no case of hepatitis or liver serious adverse event reported). 1474535
Eversmeyer W, Poland M, DeLapp RE, Jensen CP. Safety experience with nabumetone versus diclofenac, naproxen, ibuprofen, and piroxicam in osteoarthritis and rheumatoid arthritis. Am J Med 1993; 95: 10S-18S. (Major focus of analysis was on gastrointestinal side effects in this study of patients given nabumetone [n=3,315], diclofenac [296], naproxen [279], piroxicam [286] or ibuprofen [235] for 12 weeks; ALT elevations >2 to 3 times ULN occurred in 0.2 to 0.5% of patients on nabumetone, 1.1 to 4% on diclofenac, and 0.4% on naproxen, ibuprofen or piroxicam; no mention of hepatitis or jaundice). 8356997
Friedel HA, Langtry HD, Buckley MM. Nabumetone. A reappraisal of its pharmacology and therapeutic use in rheumatic diseases. Drugs 1993; 45: 131-56. (Thorough review of structure, pharmacology, efficacy and safety of nabumetone; among 1677 patients, 0.4% showed marked elevations in both ALT and AST, but no mention of clinically apparent liver injury or jaundice). 7680981
Bellamy N, Bensen WG, Beaulieu A, Siminovitch KA, Kraag GR, Lussier A, Ahmad S, et al. A multicenter study of nabumetone and diclofenac sustained release in patients with osteoarthritis. J Rheumatol 1995; 22: 915-20. (Among 382 patients enrolled in controlled trials of 6 months of nabumetone vs diclofenac, there was similar efficacy, but better tolerance with nabumetone; ALT above 2 times ULN occurred in less than 1% [n=2] of nabumetone vs 3% of diclofenac recipients; no mention of hepatitis or jaundice). 8587082
Schnitzer TJ, Ballard IM, Constantine G, McDonald P. Double-blind, placebo-controlled comparison of the safety and efficacy of orally administered etodolac and nabumetone in patients with active osteoarthritis of the knee. Clin Ther 1995; 17: 602-12. (Mild ALT elevations occurred in 3 of 89 nabumetone, none of 90 etodolac, and 2 of 90 placebo treated patients; no mention of outcome or symptoms). 8565024
Weaver A, Rubin B, Caldwell J, McMahon FG, Lee D, Makarowski W, Offenberg H, et al. Comparison of the efficacy and safety of oxaprozin and nabumetone in the treatment of patients with osteoarthritis of the knee. Clin Ther 1995; 17: 735-45. (In an analysis of a six week placebo controlled trial, ALT elevations occurred in none of 109 nabumetone, but in 9 of 109 oxaprozin treated patients). 8565037
Morgan GJ Jr, Kaine J, DeLapp R, Palmer R. Treatment of elderly patients with nabumetone or diclofenac: gastrointestinal safety profile. J Clin Gastroenterol 2001; 32: 310-4. (335 elderly patients with osteoarthritis were enrolled in randomized clinical trials of nabumetone [1 or 2 g/day] vs diclofenac for 12 weeks; ALT above 2 times ULN occurred in 0% [0/155] of nabumetone vs 4% of diclofenac recipients). 11276273
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. (NSAIDs are the most commonly used drugs in the US and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4/100,000 patient-years [rate ratio 1.5] and ~1 death/100,000 patient-years due to liver injury; not increased with age or associated with gender; in case controlled studies, higher odds ratio with sulindac, indomethacin, piroxicam and diclofenac, no mention of nabumetone). 15298630
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, 3 attributed to naproxen, but none to nabumetone). 16165719
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. (Review of randomized clinical trials of NSAIDS for frequency of adverse events; ALT above 3 times ULN in 0.43% of ibuprofen, 0.43% naproxen, 0.42% celecoxib, 1.8% rofecoxib, 3.55% diclofenac, and 0.29% of placebo recipients, rare liver related serious adverse events or deaths with any; no mention on nabumetone). 15880319
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verma A, Rothman KJ. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations. Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. (Survey of NSAID use in UK and US indicates ibuprofen, naproxen and diclofenac are the most commonly used NSAIDs; nabumetone not in top 10 agents used). 17086563
Lapeyre-Mestre M, de Castro AM, Bareille MP, Garcia del Pozo J, Requejo AA, Arias LM, Montastruc J-L, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; among more than 29,000 liver adverse event reports, only 3 were for nabumetone and no details given). 16867024
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; nabumetone not listed). 18955056
Bannwarth B. Safety of nonselective NSAID nabumetone: focus on gastrointestinal toxicity. Drug Saf 2008; 31: 485-503. (Review of chemistry, pharmacology and gastrointestinal tolerance of nabumetone; during first 7 years on the market, the frequency of hepatic adverse event reports was 3.4 per million prescriptions and serious hepatic events 1.3 per million, which was markedly lower than for diclofenac [13.6 and 4.3 per million] and similar to naproxen [1.8 and 2.9 per million] and piroxicam [0.2 and 1.2 per million]). 18484783
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; nabumetone not discussed). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 7 to NSAIDs with 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to nabumetone). 20949552
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset; including acetaminophen in 192 and NSAIDs in 44, including diclofenac [the most commonly used NSAID] in 7; nabumetone was not specifically mentioned). 23325533
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none for nabumetone or other NSAIDs). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDs [n=62, 32%], and specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most commonly diclofenac [n=16], but also celecoxib [3], meloxicam [3], etodolac [2], ibuprofen [2], oxaprozin [2], valdecoxib [1] and sulindac [1], but none for nabumetone). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] and risk was higher in those taking higher doses). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-4. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%]; nabumetone and other NSAIDs not mentioned). 28782674
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin). 29469052
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to nabumetone). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; nabumetone was not mentioned). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases due to diclofenac for an estimated incidence of 1 per 4,800 new persons treated each year, while other NSAIDs had lower numbers and estimated rates, including celecoxib [4, 1:25,000] and meloxicam [n=3, 1:87,000], there were no cases due to nabumetone and its incidence could not be estimated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen, and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam, while no case was attributed to nabumetone [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Nabumetone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Butanones/AE+AND+nabumetone%5BNM%5D+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Nabumetone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nabumetone)